# Iron

## OVERVIEW

### Introduction

Iron is an essential heavy metal that is included in many over-the-counter multivitamin and mineral supplements and is used therapeutically in higher doses to treat or prevent iron deficiency anemia. When taken at the usual recommended daily allowance or in replacement doses, iron has little or no adverse effect on the liver. In high doses and in intentional or accidental overdoses, iron causes serious toxicities, one component of which is acute liver damage.

### Background

Iron is an essential heavy metal that is a necessary component of hemoglobin and myoglobin and is found in many human enzymes. High concentrations of iron are present in red blood cells and muscle tissue. In adults, the recommended dietary allowance of iron is 8 to 11 mg per day for men and 8 to 18 mg for women in whom higher levels are recommended during pregnancy (27 mg per day). Iron is poorly absorbed and body and tissue iron stores are controlled largely by modifying rates of absorption. Adequate amounts of iron are found in most Western diets, with highest levels found in red meats and moderate levels in fish, poultry, green vegetables, cereals and grains (some of which are fortified with iron). Iron deficiency is usually due to loss of iron, predominantly as a result of blood loss in the gastrointestinal tract or from menstruation and is rarely due to deficiency in intake. Standard multivitamin tablets do not contain iron and, those that do, are usually labeled as multivitamins with iron. Iron for treatment of iron deficiency is available as various ferrous ion salts (gluconate, sulfate, fumarate), usually in concentrations of 200 to 400 mg per tablet, representing 30 to 100 mg of elemental iron. The typical recommended dose is 100 to 200 mg of elemental iron daily, which may represent 1 to 4 tablets (see Table). Iron is also available in parenteral formulations for more rapid replacement of iron stores or for patients who do not respond to oral intake. These preparations include iron sucrose and iron dextran. Common side effects of oral replacement iron preparations include gastrointestinal upset, nausea, abdominal pain, constipation and dark stools. Rare, but potentially severe adverse reactions to iron include iron overload, hypersensitivity reactions (particularly to parenteral forms) and gastrointestinal bleeding.

Concentrations of elemental iron in typical iron tablets

Salt Form | Typical Dose | Percent Fe | Elemental Iron
Ferrous sulfate (desiccated) | 325 mg | 37% | 120 mg
Ferrous sulfate (hydrated) | 325 mg | 20% | 64 mg
Ferrous fumarate | 300 mg | 33% | 99 mg
Ferrous gluconate | 325 mg | 12% | 39 mg

### Hepatotoxicity

Typical replacement doses of oral iron have not been linked convincingly to serum enzyme elevations during therapy or to idiosyncratic, acute clinically apparent liver injury. In contrast, overdoses of oral iron, whether intentional or accidental, can cause liver injury, largely as a component of iron poisoning. Iron poisoning occurs most common in toddlers (1 to 3 years old) who ingest iron tablets prescribed for adults. Toxicity occurs after ingestion of 3 grams or more of ferrous sulfate (approximately 10 tablets, or ~650 mg of elemental iron), with toxic levels being more than 60 mg/kg of elemental iron and fatal levels more than 180 mg/kg. The typical sequence of events is appearance of nausea, vomiting and abdominal pain within 1 to 3 hours of the ingestion, followed by diarrhea, weakness, irritability, lethargy and stupor. Vomitus may be blood streaked or frank hematemesis. The diarrhea is generally fluid and dark (as a result of iron rather than blood). With higher doses, this initial phase is rapidly followed by pallor, hypotension and shock. Both upper and lower gastrointestinal bleeding can occur and early changes include metabolic acidosis and coagulopathy. In some instances, there is an improvement after a few hours of symptoms which can then be followed by sudden hemodynamic collapse, cardiogenic shock and severe acidosis that may be fatal. Early intervention (with gastric lavage, fluid replacement and iron chelation) appears to ameliorate the course of injury. Liver toxicity generally arises after 24 hours and may be more common in adults than children. Severe liver toxicity, with jaundice and marked aminotransferase elevations (ALT and AST greater than 25 times ULN), generally occurs only with larger overdoses and high initial serum iron levels (>1000 μg/dL). Jaundice is initially mild, while prolongation of the prothrombin time (or INR) and acidosis arise early (Case 1). The usual cause of death from iron poisoning is cardiac arrest, but deaths from hepatic failure as well as emergency liver transplantation for iron poisoning have been reported. Interestingly, the hepatic histological findings of acute iron hepatotoxicity are those of hemorrhagic, submassive necrosis which is predominantly peri-portal (zone 1), a finding typical of direct hepatotoxins that do not require hepatic metabolism for their toxicity. With more severe toxicity, the injury is massive and pan-lobular.

Likelihood score: A[H] (well established cause of clinically apparent acute and chronic liver injury when given in high doses).

### Mechanism of Injury

Iron is clearly a direct hepatotoxin, the injury arising only after high dose exposure and manifesting as acute hepatic necrosis. The likely cause is direct cytotoxicity of elemental iron, the sudden large exposure having overwhelmed the normal serum and tissue iron binding capacities. Iron hepatotoxicity can be reproduced in animal models, although the sequence of events is different, perhaps because of the route of exposure (parenteral vs oral) and species differences in handling excess iron.

### Outcome and Management

Cases of liver injury attributed to iron poisoning have ranged from mild-to-moderate in severity (aminotransferase elevations without symptoms) to severe and rapidly fatal injury. The injury from acute exposure is generally self-limited in course and, with supportive management, resolves rapidly within 2 to 4 weeks of onset. Death from cardiac, respiratory or hepatic failure occurs in 1% to 3% of cases. A late complication of iron poisoning is gastric or intestinal obstruction due to strictures caused by the direct gastrointestinal mucosal injury. There is no reason to believe that subsequent use of oral iron in normal amounts is contraindicated.

Drug Class: Trace Elements and Metals

## CASE REPORT

### Case 1. Acute liver failure due to overdose of ferrous sulfate in a young adult.

[Modified from: Daram SR, Hayashi PH. Acute liver failure due to iron overdose in an adult. South Med J 2005; 98: 241-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/15759960)]

An 18 year old woman took an overdose of ferrous sulfate (~100 tablets of 325 mg each) and developed nausea, vomiting and abdominal pain shortly thereafter. She was taken to an emergency room and admitted within 5 hours of the exposure. She had no other significant medical illnesses, was taking no medications (the iron tablets were not hers) and had no history of liver disease, excess alcohol intake or risk factors for viral hepatitis. The estimated total dose of iron ingested was 32.5 g of ferrous sulfate, which was equivalent to 120 mg of elemental iron per kg body weight. On admission, she was still vomiting with mild hematemesis and pill fragments in the vomitus. She had tachycardia (97/minute), but vital signs were otherwise normal, and she was alert and oriented. She underwent gastric lavage and was started on intravenous deferoxamine. Serum iron levels were elevated, but not markedly (340 μg/dL; normal <158) while renal, coagulation and hepatic tests were normal. The following day, however, she became lethargic and was found to be jaundiced. Serum aminotransferase levels were markedly elevated (ALT 4,048 U/L, AST 2,417 U/L) and INR had risen to 5.0 (Table). She was treated with oral N-acetylcysteine and was transferred to a liver transplant center. Tests for hepatitis A, B and C were negative as were autoantibodies. However, her liver tests were stable, over the following 4 days she continued to improve and she was discharged on hospital day 6. In follow up one week later, she was asymptomatic and liver tests were normal or near normal.

#### Key Points

Medication: | Ferrous sulfate (100 tablets of 325 mg; ~6.4 g elemental iron)
Pattern: | Hepatocellular (R=~100)
Severity: | 4+ (jaundice, hospitalization, hepatic failure)
Latency: | 24 hours
Recovery: | Unclear, ~4 weeks
Other medications: | None

#### Laboratory Values

Time After Overdose | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | INR | Comments
<24 hours | 14 | 59 | 0.3 | 1.0 | Admission, 5 hours after overdose
1 day | 4,048 | 87 | 3.1 | 5.0
2 days | 3,618 | 84 | 2.3 | 5.8 | Transferred
3 days | 2,642 | 85 | 2.3 | 4.0
4 days | 1,657 | 85 | 2.4 | 2.7
5 days | 1,438 | 107 | 2.8 | 1.1 | Discharged
2 weeks | 362 | | 0.9 | 0.9 | Asymptomatic
Normal Values | <41 | <129 | <1.2 | <1.2

#### Comment

Iron poisoning typically occurs in toddlers who ingest iron tablets meant for their parents. In adults, iron overdose occurs typically as a result of a suicide attempt. When initially reported in the 1940s and 1950s, the mortality rate of iron poisoning was in excess of 50%. In more recent series, however, the death rate has been much lower, in the range of 1% to 3%. Liver injury from iron poisoning is often mentioned and can be severe, but is rarely the primary cause of death. As in this case, hepatic injury generally arises after the first day and is often overshadowed by other manifestations, such as cardiac failure, sepsis, acidosis, gastrointestinal bleeding or coagulopathy. In general surveys, severe liver injury is reported in 15% of cases of iron poisoning, generally in association with higher exposures, higher initial iron levels (above 1000 μg/dL) and more severe injury. Liver injury appears to be more common in adults than children, or at least it is better documented, as most instances of deaths from hepatic failure or emergency liver transplantation from iron overdoses have been reported in adults taking iron with suicidal intent.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ferrous Fumarate - Generic, Feostat®

Ferrous Glconate - Generic, Fergon®

Ferrous Sulfate - Generic, Feratab®

DRUG CLASS

Trace Elements and Metals

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ferrous)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ferrous Fumarate | 141-01-5 | C4-H4-O4.Fe | Image of Ferrous Fumarate Chemical Structure
Ferrous Gluconate | 299-29-6 | C12-H22-Fe-O14 | Image of Ferrous Gluconate Chemical Structure
Ferrous Sulfate | 7720-78-7 | Fe.H2-O4-S | Image of Ferrous Sulfate Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 April 2018

Zimmerman HJ. Iron poisoning. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp 346-7. (Review of hepatotoxicity published in 1999 mentions that liver injury is a known component of iron poisoning, typically occurring in toddlers, resembling acute hepatic necrosis and arising between 1-3 days after exposure).
Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Textbook on hepatotoxicity; the acute hepatotoxicity of iron is not discussed).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1872-6. (Textbook of pharmacology and therapeutics).
Forbes G. Poisoning with a preparation of iron, copper, and manganese. Br Med J 1947; 1(4498): 367-70. (Initial modern report of two children, ages 1 and 3 years, who took 30-50 tablets of iron [10-16 g] and developed gastrointestinal distress followed by temporary improvement and then pallor, tachycardia and shock and dying within 30-53 hours; in one case, the autopsy was said to show acute liver failure). 20289621
Thomson J. Two cases of ferrous sulphate poisoning. Br Med J 1947; 1 (4505): 640. (Two cases reported in response to Forbes [1947]; 16 month old girl swallowed 40 tablets of ferrous sulfate [with small amounts of copper and manganese] and rapidly developed vomiting, lethargy and hematemesis, with improvement after gastric lavage and iv fluids, but sudden deterioration, shock and death several hours later, autopsy showing gastric erosions and necrosis; 2 year old boy swallowed 10 tablets of ferrous sulfate and rapidly developed vomiting, dark diarrhea and lethargy, recovering with conservative management). 20248077
Somers GF. Relative oral toxicity of some therapeutic iron preparations. Br Med J 1947; 2 (4518): 201-3. (Analysis of toxicity of various iron preparations in 3 species of animals found toxicity only at high doses, similar among most formulations, correlated with elemental iron concentration, ferrous iron less toxic than ferric, and histology in lethal cases showing minimal organ damage, with only slight swelling of hepatocytes; concluding that, "iron preparations should be kept out of reach of the very young"). 20255537
Edge ND, Somers GF. Effect of dimercaprol in acute iron poisoning. Pharm J 1948; 107: 216. (Study of toxicity of ferrous sulfate and chloride given orally or intravenously to mice found that dimercaprol increased toxicity when given after iron exposures and decreased toxicity when given before, but only with ferrous sulfate). 18885636
Foucar FH, Gordon BS, Kaye S. Death following ingestion of ferrous sulfate. Am J Clin Pathol 1948; 18: 971-3. (26 year old man accidentally ingested aqueous ferrous sulfate solution, rapidly developing vomiting, abdominal pain and rigidity, cyanosis and shock, dying within 3 hours; autopsy showed necrotic gastric mucosa and hepatic degeneration, but little evidence of iron absorption or staining of tissues outside of the stomach). 18105521
Prain JH. Fatal poisoning of an infant by antianemic pills containing iron, manganese, and copper. Br Med J 1949; 2 (4635): 1019, pl. (11 month old girl took an unknown number of antianemia tablets of ferrous sulfate with copper and manganese and rapidly developed vomiting and drowsiness, later improving, but suddenly deteriorating the following day with cyanosis and shock and death 39 hours after the ingestion, autopsy showing hepatic steatosis with scant iron). 15406860
Smith RP, Jones CW, Cochran WE. Ferrous sulfate toxicity; report of a fatal case. N Engl J Med 1950; 243: 641-5. (17 month old girl ingested an unknown number of ferrous sulfate tablets and developed vomiting and diarrhea, followed by stupor and cyanosis, marked ecchymoses, shock, coma, convulsions and death within 12 hours of the exposure). 14780348
Murphy JW, Neustein C, Hoffman AC, Winters HV, Gaskins AL. Acute iron poisoning. Report of a case and review of the literature. Arch Pediatr 1951; 68: 303-8. (30 month old girl developed severe vomiting shortly after swallowing 75 ferrous sulfate tablets that her mother was given after donating blood and was treated with gastric lavage and iv fluids; she had a day of diarrhea and vomiting, but then remained well and was discharged). 14857918
Spencer IO. Ferrous sulphate poisoning in children. Br Med J 1951; 2 (4740): 1112-7. (Description of 8 cases of iron poisoning in children, 3 girls and 5 boys, ages 11 to 23 months who took 3-54 tablets, presenting within 1-7 hours, usual symptoms of vomiting, pallor, drowsiness and hematemesis, 4 dying in 4-24 hours). 14869831
Branch LK. Ferrous sulfate poisoning; report of a fatal case. Pediatrics 1952 Dec; 10 (6): 677-80. (29 month old boy was found eating ferrous sulfate tablets and underwent gastric lavage within 30 minutes, but he then developed vomiting, hematemesis and black stools followed by cyanosis, coma and death within 5 hours of the ingestion). 13003416
Duffy TL, Diehl AM. Ferrous sulfate poisoning. Report of three cases. J Pediatr 1952; 40: 1-5. (15, 18 and 26 month old children, 2 girls and 1 boy, swallowed adult, chocolate favored, ferrous sulfate tablets and rapidly developed vomiting followed by black stools and lethargy, one recovering within 2 and one within 5 days, the third dying of progressive shock and cardiac failure within 5 hours of the ingestion and autopsy showing necrotic gastric mucosa). 14898410
Swift SC, Cefalu V, Rubell EB. Ferrous sulfate poisoning; report of a fatal case. J Pediatr 1952; 40: 6-10. (19 month old boy swallowed enteric coated ferrous sulfate tablets and began to vomit within 30 minutes, then developing lethargy, diarrhea, red liquid stools, cyanosis, hypotension, fever and respiratory failure, dying 40 hours after exposure, autopsy showing central necrosis of the liver, but without iron staining). 14898411
Luongo MA, Bjornson SS. The liver in ferrous sulfate poisoning; a report of three fatal cases in children and an experimental study. N Engl J Med 1954; 251: 995-9. (3 cases of fatal overdose of ferrous sulfate in 12 to 18 month old children who died within 48 hours, and autopsies showed marked peri-portal hepatic necrosis (zone 1) with leukocytic infiltrates and mild-to-moderate fatty metamorphosis). 13214376
Shoss J. Ferrous sulfate poisoning; a case treated with BAL. J Pediatr 1954; 44: 77-8. (14 month old girl swallowed 50-75 ferrous sulfate tablets and was admitted with lethargy and vomiting 3 hours later, semicomatose, cyanotic, febrile and in shock, treated with gastric lavage and intramuscular BAL, with slow improvement and discharge after 5 days). 13131201
Curtiss CD, Kosinski AA. Fatal case of iron intoxication in a child. J Am Med Assoc 1954; 156: 1326-8. (21 month old girl ingested unknown number of ferrous sulfate tablets and developed vomiting, stupor, coma and sudden death 48 hours after the ingestion; liver showing irregular pattern of necrosis). 13211245
Clark WM Jr, Jurow SS, Walford RL, Warthen RO. Ferrous sulfate poisoning. AMA Am J Dis Child 1954; 88: 220-6. (Two cases of iron poisoning; 15 month old girl took 5.5 g of ferrous sulfate and rapidly developed vomiting, black diarrhea and fever, but recovered within 3 days; 20 month old girl took 10-12 g of ferrous sulfate and developed bloody diarrhea, vomiting, pallor, shock and death within 20 hours, autopsy showed an infarcted ileum and there was little iron in the liver). 13180017
Kaplan BB, Schliefer DM. Ferrous sulfate poisoning; a nonfatal case. AMA Am J Dis Child 1954; 88: 348-9. (13 month old girl took ~2 g of ferrous sulfate and developed blood stained vomiting, drowsiness, diaphoresis and shock [serum iron 10 times ULN], was treated with gastric lavage, transfusions and fluids and recovered in 3-4 days). 13188454
Birk RE, Stallard SK. Acute ferrous sulfate poisoning: report of a nonfatal case. J Pediatr 1954; 45: 164-8. (26 month of girl presented 2 hours after ingesting 65 tablets of ferrous sulfate [~13 g], was treated with fluids, lavage, blood transfusions and BAL and recovered fully within 4-6 days; review of 30 cases from literature). 13184390
Reissman KR, Coleman TJ, Budai BS, Moriarty LR. Acute intestinal iron intoxication. I. Iron absorption, serum iron and autopsy findings. Blood 1955; 10: 35-45. (Studies of ferrous sulfate overdose in rabbits and dogs found fatal dose to be ~200 mg/kg, but autopsies showed minimal gastrointestinal mucosal or hepatic damage). 13219186
Brown RJ, Gray JD. The mechanism of acute ferrous sulphate poisoning. Can Med Assoc J 1955; 73: 192-7. (2 year old boy swallowed 40 ferrous sulfate tablets and developed vomiting and semi-coma, followed by pallor and cyanosis and persistent vomiting, developing jaundice after 24 hours, coma, convulsions, but ultimately recovered although he required surgery for pyloric stenosis, at which time a liver biopsy was minimally abnormal). 13240579
Charney E. A fatal case of ferrous sulfate poisoning. JAMA 1961 Oct 21; 178: 326-7. (16 month old girl ingested unknown number of ferrous sulfate tablets and was found semi-comatose with gastrointestinal bleeding, acidosis, coagulopathy and cardiac failure, followed by death 17 hours after the ingestion, autopsy showing gastrointestinal mucosal necrosis and hemorrhage; "the liver was unremarkable"). 13878304
Dugdate AE, Powell LW. Acute iron poisoning: its effects and treatment. Med J Aust 1964; 2: 990-2. (3 cases of acute iron poisoning from Australia: 17 month old boy swallowed more than 100 ferrous sulfate tablets and was admitted drowsy and pale one hour later, becoming stable with fluid replacement, but then deteriorating and dying 30 hours after the ingestion, autopsy showing severe necrosis; 22 month old girl took 60 tablets of ferrous sulfate, began to vomit and developed circulatory failure [serum iron 4800 μg/dL], was treated with deferoxamine and had transient liver injury [peak bilirubin 2.7 mg/dL], but ultimately recovered; 20 year old pregnant woman took 60 ferrous sulfate tablets with sodium amytal and aspirin and developed hypotension [serum iron 465 μg/dL], was treated with an iron chelating agent and recovered and delivered a normal child several months later). 14226570
Santos AS, Pisciotta AV. Acute iron intoxication. Treatment with desferrioxamine E(BA-29837). Am J Dis Child 1964; 107: 424-7. (14 year old girl swallowed 10 ferrous sulfate tablets and began vomiting within 20 minutes and was admitted with diarrhea, lethargy and semicoma [serum iron 575 μg/dL], treated with deferoxamine and recovered fully within 6 days). 14109504
Covey TJ. Ferrous sulfate poisoning: a review, case summaries, and therapeutic regimen. J Pediatr 1964; 64: 218-26. (Description of 4 of 20 cases of iron poisoning seen at Cook County Hospital, Chicago during a 1 year period; the single fatal case had massive liver necrosis). 14119521
Walsh JR, Gillick JB. Iron chelation in acute iron poisoning and chronic hypersiderosis. Clin Pediatr (Phila) 1965; 4: 633-8. (Review of the rationale for iron chelation using deferoxamine for acute iron poisoning and clinical guidance to its use). 5844429
Barr DG, Fraser DK. Management of acute iron poisoning. Br Med J 1965; 1(5435): 657. (Letter on use of deferoxamine in iron poisoning mentioning a case with massive hepatic necrosis and cautioning against use of drugs with potential of worsening hepatic injury). 14245190
Jacobs J, Greene H, Gendel BR. Acute iron intoxication. N Engl J Med 1965; 273: 1124-7. (17 month old girl took an unknown number of ferrous sulfate tablets and developed abdominal pain, vomiting and watery diarrhea 45 minutes later; on admission, serum iron was 1162 µg/dL and she was treated with gastric lavage and deferoxamine and recovered; review of literature on use of deferoxamine represented by case reports only). 5841675
Gevirtz NR, Rausen AR. Acute iron poisoning. Clinical and laboratory observations with deferoxamine. J Mt Sinai Hosp N Y 1966; 33: 64-8. (18 month old boy swallowed an unknown number of his mother's ferrous sulfate tablets and developed vomiting followed by lethargy and then coma; initial serum iron of 800 μg/dL fell to normal with starting iv, sc and oral deferoxamine and he recovered and was discharged after 6 days). 5215561
Westlin WF. Deferoxamine in the treatment of acute iron poisoning. Clinical experiences with 172 children. Clin Pediatr(Phila) 1966; 5: 531-5. (Analysis of results of deferoxamine therapy of acute iron poisoning in 172 children, ages 9 months to 18 years [all but 2 were below age 5], 81 boys and 76 girls, 86% with symptoms, vomiting [80%], drowsiness [52%], diarrhea [48%], with shock in 19 [11%], coma in 18 [10%] and 3 deaths [1.7% overall, 11% of those with shock or coma]; initial iron levels correlated with subsequent severity, shock or coma arising in 70% if >1000 μg/dL; side effects of deferoxamine included flushing or rash in 3 and transient hypotension in 4). 5911317
Leikin S, Vossough P, Mochir-Fatemi F. Chelation therapy in acute iron poisoning. J Pediatr 1967; 71: 425-30. (22 children with iron poisoning were treated with either standard care, deferoxamine orally or both orally and intravenously; all patients recovered and initial serum iron levels of 250 to 800 µg/dL fell to normal within 24 hours in all patients regardless of deferoxamine use; urinary excretion was greater with deferoxamine treatment). 6034795
Coli RD, Leone LA, Albala MM. Treatment of acute iron intoxication with deferoxamine: a report of six cases. Chelating agent proves effective in management of acute iron poisoning. R I Med J 1967; 50: 549-53 (Six children, ages 15 to 22 months, with acute iron poisoning [3-19 g of ferrous sulfate] were treated with deferoxamine orally and parenterally and 5 survived; no adverse effects were noted). 5235587
Keller P, Schneider V. [Accidental iron sulfate poisoning in a 3-year-old child]. Monatsschr Kinderheilkd 1968; 116: 476-8. German. (3 year old boy developed severe vomiting and abdominal distress and was found to have a gastric perforation and had progressive cardiac and respiratory failure after emergency surgery, subsequent investigation suggesting that he had swallowed a car battery powder that contained ferrous sulfate). 5720561
Barr DG, Fraser DKB. Acute iron poisoning in children: role of chelating agents. BMJ 1968; 737-41. (Analysis of outcome of treating iron poisoning with chelating agents [mostly deferoxamine]; 16 children, ages 1 to 6 years with initial serum iron of 390-3000 μg/dL were treated with oral and/or parenteral agents, one fatality [with highest iron levels], no apparent adverse effects of treatment, and all were normal in follow up). 5641439
Movassaghi N, Purugganan GG, Leikin S. Comparison of exchange transfusion and deferoxamine in the treatment of acute iron poisoning. J Pediatr 1969; 75: 604-8. (In dogs, exchange transfusion resulted in 30 times greater removal of iron than did deferoxamine infusions, but the animals were in shock with little urinary output). 5809838
Whitten CF, Brough AJ. The pathophysiology of acute iron poisoning. Clin Toxicol 1971 4: 585-95. (Review of pathophysiology of acute iron toxicity mentions that signs of hepatic dysfunction arise 3-4 days after exposure with rises in serum bilirubin and lactic acidosis, possibly due to hepatic mitochondrial injury). 5317453
Rueff B, Benhamou JP. Acute hepatic necrosis and fulminant hepatic failure. Gut 1973; 14: 805-15. (Review of the clinical features, causes and management of acute liver failure: no cases were attributed to iron). 4586083
Ganote CE, Nahara G. Acute ferrous sulfate hepatotoxicity in rats. An electron microscopic and biochemical study. Lab Invest 1973; 28: 426-36. (Study of acute iron hepatic injury in rats given ferrous sulfate orally [250-500 mg/kg] found early swelling of hepatocytes and mitochondrial changes, followed by frank necrosis that was predominantly periportal or mid-zonal). 4574197
Gjone E, Stave R. Liver disease associated with a "non-constipating" iron preparation. Lancet 1973; 1 (7800): 421-2. (Two women ages 21 and 68 years developed jaundice and ascites having taken an iron preparation for 6 months and 4 years that also included oxyphenasitin, a known hepatotoxin that causes a progressive, autoimmune hepatitis-like syndrome). 4119723
Eriksson F, Johansson SV, Mellstedt H, Stranberg O, Wester PO. Iron intoxication in two adult patients. Acta Med Scand 1974; 196: 231-6. (Two patients with iron poisoning; 19 year old woman took overdose of 60 tablets of ferrous succinate, developing abdominal pain, vomiting and lethargy [plasma iron 350 μg/dL], liver tests were normal and she recovered within 1 week; 26 year old woman took an overdose of 150 tablets of ferrous succinate developing vomiting, lethargy and dehydration [plasma iron 640 μg/dL], was treated with deferoxamine and developed jaundice on day 2 [bilirubin rising to 17.2 mg/dL and ALT to 421 U/L], resolving over the following 2 weeks). 4417152
Robotham JL, Troxler RF, Lietman PS. Iron poisoning: another energy crisis. Lancet 1974; 2 (7881): 664-5. (Letter suggesting mechanism of hepatic injury from iron poisoning is mediated by mitochondrial injury). 4137783
Murphy BF. Editorial: Hazards of children's vitamin preparations containing iron. JAMA 1974; 229: 324. (Editorial raising concern regarding use of flavored, chewable iron containing multivitamins for children). 4406797
Strom RL, Schiller P, Seeds AE, Bensel RT. Fatal iron poisoning in a pregnant female. Minn Med 1976; 59: 483-9. (17 year old, pregnant adolescent female took an overdose of 95 tablets of iron in a suicide attempt and soon developed vomiting and diarrhea [serum iron 1700 μg/dL], was treated with gastric lavage alone and went on to develop coma, acidosis, hypoglycemia, coagulopathy, gastrointestinal bleeding, and hepatic, respiratory and renal failure, spontaneously aborting on the 2nd and dying on the 3rd hospital day; at autopsy, the liver showed prominent periportal necrosis, but the fetus showed no abnormalities and no excess iron). 1086955
Greenblatt DJ, Allen MD, Kock-Weser J. Accidental iron poisoning in childhood. Six cases including one fatality. Clin Pediatr (Phila) 1976; 15: 835-8. (Among 76 admissions for accidental poisoning in children, 6 were due to iron, 2 mild [serum iron <400 µg/dL], 2 moderate [iron 400-1000 µg/dL] and 2 severe [1556 and 2160 µg/mL], the one fatal case having severe hepatic necrosis, but death was due to cardiac arrest). 954339
deCastro FJ, Jaeger R, Gleason WA Jr. Liver damage and hypoglycemia in acute iron poisoning. Clin Toxicol 1977; 10: 287-9. (16 month of boy ingested ~15 g of ferrous sulfate and developed irritability, vomiting, dark diarrhea and lethargy and was admitted 2 hours later in shock [serum iron 5000 µg/dL], with hepatic injury arising on day 3 [bilirubin 5.9 rising to 10.6 mg/dL, ALT 1100 U/L, LDH 1200 U/L], with subsequent confusion, hypoglycemia and death on day 5). 862362
Gleason WA Jr, deMello DE, deCastro FJ, Connors JJ. Acute hepatic failure in severe iron poisoning. J Pediatr 1979; 95: 138-40. (18 month old boy became obtunded within 8 hours of swallowing ~3.5 g of elemental iron [50-60 ferrous sulfate tablets] and progressed to hepatic and circulatory failure within 2 days despite deferoxamine [peak bilirubin 7.6 mg/dL, AST 9011 U/L], autopsy showing hemorrhagic necrosis that was panlobular, but most prominent in zone 1 [periportal]). 479996
Krenzelok EP, Hoff JV. Accidental childhood iron poisoning: a problem of marketing and labeling. Pediatrics 1979; 63: 591-6. (Discussion of issues that account for accidental ingestion of iron by toddlers including the general availability of iron tablets, use of sugar or attractive coating, lack of knowledge about the dangers of iron, lack of child-resistant containers and variability of iron concentrations; listing of commercial iron products and concentrations of elemental iron). 440869
Robotham JL, Lietman PS. Acute iron poisoning. A review. Am J Dis Child 1980; 134: 875-9. (Review of acute iron toxicity, clinical features, pathophysiology and management). 6998282
Doolin EJ, Drueck C 3rd. Fatal iron intoxication in an adult. J Trauma 1980; 20: 518-22. (18 year old man fell into a vat of ferrous chloride and jumped out quickly, but was admitted in critical condition with chemical burns, improving initially, but developing severe acidosis, coagulopathy, and progressive respiratory, renal and hepatic failure and death within 5 days, autopsy showing severe hepatic necrosis without a zonal pattern). 7373684
Peterson CD, Fifield GC. Emergency gastrotomy for acute iron poisoning. Ann Emerg Med 1980; 9: 262-4. (15 month old female swallowed 10-15 ferrous sulfate tablets, was seen within 45 minutes, x-rays showing a clump of radioopague pills in stomach; she underwent gastrotomy and removal of tables, whereupon she recovered uneventfully, serum iron levels decreasing from 240 to 98 μg/dL). 7369579
Venturelli J, Kwee Y, Morris N, Cameron G. Gastrotomy in the management of acute iron poisoning. J Pediatr 1982; 100: 768-9. (17 year old male swallowed ~43 tablets of ferrous fumarate [200 mg each] and was admitted 2.5 hours later and found to have an iron bezoar in stomach that did not respond to ipecac or gastric lavage and was removed by gastrotomy, the child recovering without signs of iron toxicity and peak serum iron of 177 μg/dL). 7069540
Evensen SA, FøR, Opedal I, Stormorken H. Acute iron intoxication with abruptly reduced levels of vitamin K-dependent coagulation factors. Scand J Haematol 1982; 29: 25-30. (17 year old girl swallowed 50 iron tablets [~5 g of elemental iron] and rapidly developed abdominal pain, vomiting and diarrhea, followed by hypotension, acidosis and coagulopathy with slow recovery in levels of vitamin K dependent coagulation factors and transient liver injury [AST rising from 80 to 1296 U/L; bilirubin 1.2 to 5.0 mg/dL by day 3]). 7123152
Henretig FM, Karl SR, Weintraub WH. Severe iron poisoning treated with enteral and intravenous deferoxamine. Ann Emerg Med 1983; 12: 306-9. (18 month old boy swallowed an estimated 60 tablets of ferrous sulfate [~3.5 g elemental iron] and presented 45 minutes later with obtundation, vomiting, diarrhea, acidosis and shock [serum iron 6798 µg/dL], responding to fluids and deferroxamine infusions and recovering within 7 days, returning 6 weeks later with intestinal obstruction due to a jejunal stricture). 6625282
Henretig FM, Temple AR. Acute iron poisoning in children. Clin Lab Med 1984; 4: 575-86. (Review of acute iron toxicity, pathophysiology, clinical manifestations and management). 6148170
Foxford R, Goldfrank L. Gastrotomy--a surgical approach to iron overdose. Ann Emerg Med 1985; 14: 1223-6. (19 year old man took an overdose of ferrous sulfate and acetaminophen [12 g] and was treated with ipecac one hour later, an x-ray showing a radio-opaque mass in the stomach that did not decrease with gastric lavage and led to gastrotomy and manual removal of the tablets, after which he recovered uneventfully with normal serum ALT levels). 4061998
Tenenbein M. Whole bowel irrigation for toxic ingestions. J Toxicol Clin Toxicol 1985; 23(2-3): 177-84. (Description of outcome in 8 children with accidental poisonings [2 with iron] who were treated with whole bowel irrigation using large-bore nasogastric tube flush and infusion until rectal effluent was clear [2-21 L over 3-24 hours]). 4057311
Proudfoot AT, Simpson D, Dyson EH. Management of acute iron poisoning. Med Toxicol 1986; 1: 83-100. (Extensive review of the clinical features of iron poisoning, its pathophysiology, diagnosis, assessment of severity and management). 3784842
Banner W Jr, Tong TG. Iron poisoning. Pediatr Clin North Am 1986; 33: 393-409. (Review of the clinical manifestations, diagnosis, assessment and treatment of iron poisoning in children discussing the use of serum iron levels and clinical symptoms to guide therapy, including oral and intravenous deferoxamine chelation). 2870463
Landsman I, Bricker JT, Reid BS, Bloss RS. Emergency gastrotomy: treatment of choice for iron bezoar. J Pediatr Surg 1987; 22: 184-5. (23 month old girl developed lethargy after taking ~60 enteric coated ferrous sulfate tablets [serum iron 352 µg/dL] and was found to have an iron bezoar in the stomach which was removed surgically and she recovered uneventfully, without further evidence of iron toxicity). 3820024
Wiseman HM, Guest K, Murray VS, Volans GN. Accidental poisoning in childhood: a multicentre survey. 1. General epidemiology. Hum Toxicol 1987; 6: 293-301. (Prospective study from 14 centers identified 2043 accidental poisonings in children [0-5 years] over a 2 year period, including 1212 [59%] due to drugs and 25 attributed to iron, but none were admitted to an intensive care unit and none died). 3623575
Wiseman HM, Guest K, Murray VS, Volans GN. Accidental poisoning in childhood: a multicentre survey. 2. The role of packaging in accidents involving medications. Hum Toxicol 1987; 6: 303-14. (Survey of poisoned children and matched controls found child-resistant containers and blister packs to be significantly associated with a lower risk of accidental poisoning, but iron was not specifically discussed). 3623576
Dean BS, Krenzelok EP. Multiple vitamins and vitamins with iron: accidental poisoning in children. Vet Hum Toxicol 1988; 30: 23-5. (Review of 275 cases of an overdose with pediatric vitamin and mineral supplements [iron ingestion of 0.9 to 77.5 mg/kg] found that no child required admission or had evidence of significant iron toxicity, and 90% were managed at home). 3354178
Mueller PD, Benowitz NL. Toxicologic causes of acute abdominal disorders. Emerg Med Clin North Am 1989; 7: 667-82. (Review of gastrointestinal toxicity of agents including iron, mercury and copper). 2663462
Everson GW, Oudjhane K, Young LW, Krenzelok EP. Effectiveness of abdominal radiographs in visualizing chewable iron supplements following overdose. Am J Emerg Med 1989; 7: 459-63. (Retrospective analysis of abdominal x-rays done on 30 children after overdose of chewable pediatric iron supplements found radioopaque material in only one case, despite experiments showing that the tablets were opaque when dispersed in water). 2757710
Schauben JL, Augenstein WL, Cox J, Sato R. Iron poisoning: report of three cases and a review of therapeutic intervention. J Emerg Med 1990; 8: 309-19. (3 cases, two toddlers with accidental overdose and an 18 year old pregnant woman with suicidal overdose of ferrous sulfate [serum iron on admission 82, 320 and 289 μg/dL] were treated with deferoxamine and gastric lavage and whole bowel irrigation, with recovery in all three; the pregnant woman delivering a normal child 14 weeks later). 2197323
Tennebein M, Wiseman N, Yatscoff RW. Gastrotomy and whole bowel irrigation in iron poisoning. Pediatr Emerg Care 1991; 7: 286-8. (13 year old girl took an overdose of ferrous sulfate, was seen 3 hours later with x-rays showing at least 50 tablets in the stomach [serum iron 320 μg/dL], and underwent whole bowel irrigation, gastrotomy and deferoxamine therapy). 1754488
Litovitz T, Manoguerra A. Comparison of pediatric poisoning hazards: an analysis of 3.8 million exposure incidents. A report from the American Association of Poison Control Centers. Pediatrics 1992; 89 (6 Pt 1): 999-1006. (Among 3.8 million poison exposures in children [<6 years] reported to poison centers from 1985 to 1987, 2117 had a major clinical outcome and 14 died: "Iron supplements were the single most frequent cause of pediatric unintentional ingestion fatalities, accounting for 30.2%" of cases due to pharmaceutical ingestions). 1594365
Lacoste H, Goyert GL, Goldman LS, Wright DJ, Schwartz DB. Acute iron intoxication in pregnancy: case report and review of the literature. Obstet Gynecol 1992; 80 (3 Pt 2): 500-1. (17 year old pregnant female [27 weeks gestation] developed abdominal pain, nausea and vomiting shortly after ingesting 50 ferrous sulfate tablets [serum iron 413 μg/dL] and recovered with deferoxamine therapy within 2 days and delivered a healthy child 10 weeks later). 1495721
Chyka PA, Butler AY. Assessment of acute iron poisoning by laboratory and clinical observations. Am J Emerg Med 1993; 11: 99-103. (Among 65 children with iron poisoning seen at a single referral hospital over a 16 year period who had serum iron testing done within 1-6 hours of ingestion, serum iron levels ranged from 200-1,500 μg/dL and severity and outcome correlated poorly with initial levels, except coma being more frequent with levels >500 μg/dL). 8476468
Anderson AC. Iron poisoning in children. Curr Opin Pediatr 1994; 6: 289-94. (Review of assessment and management of acute iron poisoning in children with discussion of dose, clinical presentation and treatment, including induction of vomiting, gastric lavage, whole bowel irrigation, gastrotomy and deferoxamine). 7914796
Kozaki K, Egawa H, Garcia-Kennedy R, Cox KL, Lindsay J, Esquivel CO. Hepatic failure due to massive iron ingestion successfully treated with liver transplantation. Clin Transplant 1995; 9: 85-7. (3 year old girl swallowed an unknown number of sugar coated ferrous sulfate tablets and developed vomiting and lethargy [serum iron 21,680 μg/dL], was treated with gastric lavage and deferoxamine, but developed worsening hypotension, acidosis, coma, renal and hepatic failure [ALT 7330 U/L, bilirubin 20.4 mg/dL], undergoing liver transplantation on day 5 with excellent recovery; explant showed massive necrosis). 7599407
Cheney K, Gumbiner C, Benson B, Tenenbein M. Survival after a severe iron poisoning treated with intermittent infusions of deferoxamine. J Toxicol Clin Toxicol 1995; 33: 61-6. (22 month old boy ingested ~18 g of ferrous sulfate and developed coma, acidosis, cardiogenic shock, coagulopathy and liver failure [bilirubin rising from 1.7 at admission to 14.8 mg/dL at 48 hours, ALT <3 to 2843, Alk P 312 to 248 U/L], eventually resolving with deferoxamine therapy, but found to have pyloric stenosis during recovery). 7837315
Chyka PA, Butler AY, Holley JE. Serum iron concentrations and symptoms of acute iron poisoning in children. Pharmacotherapy 1996; 16: 1053-8. (Among 92 children with acute iron ingestion seen at a single referral center over a 16 year period, initial serum iron levels correlated poorly with subsequent clinical severity of poisoning, with considerable overlap in values of those with and without cardiac instability). 8947978
Howland MA. Risks of parenteral deferoxamine for acute iron poisoning. J Toxicol Clin Toxicol 1996; 34: 491-7. (Review of literature on adverse events attributed to deferoxamine therapy mostly in treatment of chronic iron overload, focused upon hypotension, pulmonary, ocular and otic toxicity and infections; no mention of hepatic injury). 8800186
Morse SB, Hardwick WE Jr, King WD. Fatal iron intoxication in an infant. South Med J 1997; 90: 1043-7. (13 month old boy was brought to hospital with respiratory failure, metabolic acidosis and gastrointestinal bleeding [serum iron 5939 μg/dL], with subsequent shock and death within 13 hours of presentation). 9347819
Pestaner JP, Ishak KG, Mullick FG, Centeno JA. Ferrous sulfate toxicity: a review of autopsy findings. Biol Trace Elem Res 1999; 69: 191-8. (Review of autopsies from the Armed Forces Institute of Pathology of 11 children [5 boys, 6 girls, ages 11 to 36 months] who died of acute iron poisoning within 6-42 hours of ingestion; all had stomach or intestinal involvement and 5 had liver involvement marked by periportal(zone 1) necrosis with coagulative degeneration, cytoplasmic eosinophilia, variable dropout, mild-to-moderate iron staining of necrotic hepatocytes: "The damage to liver cells is probably related to direct toxicity by the metal"). 10468156
Morris CC. Pediatric iron poisonings in the United States. South Med J 2000; 93: 352-8. (Analysis of pediatric iron poisoning reported between 1980 and 1996 in the US showed a rise from 820 in 1980 to a peak of 2930 cases in 1989 and falling then to 2370 in 1996, with average number of deaths increasing from 2.7 to 6.3 despite use of child-resistant containers, which were sometimes left open, or were opened by other children or by the ingestee). 10798501
Maclachlan D, Tyndall A. Acute hepatitis in adult Still's disease apparently resulting from oral iron substitution--a case report. Clin Rheumatol 2000; 19: 222-5. (22 year old woman with adult onset Still disease had marked ALT elevation [1589 U/L] one day after starting ferrous fumarate [300 mg twice daily], which fell to baseline within 10 days of stopping; she also received indomethacin and methylprednisolone). 10870659
Tenenbein M. Hepatotoxicity in acute iron poisoning. J Toxicol Clin Toxicol 2001; 39: 721-6. (Review of clinical features, animal studies, mechanism of injury and therapy of acute iron toxicity). 11778670
Black J, Zenel JA. Child abuse by intentional iron poisoning presenting as shock and persistent acidosis. Pediatrics 2003; 111: 197-9. (7 week old male infant was admitted with unexplained metabolic acidosis [ALT 1555 U/L, Alk P 551 U/L] and was found to have elevated iron levels [308 μg/dL], mother later admitting to physical abuse and feeding infant crushed iron tablets). 12509576
Velez LI, Gracia R, Mills LD, Shepherd G, Feng SY. Iron bezoar retained in colon despite 3 days of whole bowel irrigation. J Toxicol Clin Toxicol 2004; 42: 653-6. (16 month old boy swallowed an unknown number of ferrous sulfate tablets, developed vomiting 18 hours later [serum iron 429 μg/dL] and had multiple opaque tablets in stomach and intestines by x-ray; he was treated with whole bowel irrigation until effluent was clear, but still had a colonic bezoar that was passed only after resumption of a normal diet). 15462159
Robertson A, Tenenbein M. Hepatotoxicity in acute iron poisoning. Hum Exp Toxicol 2005; 24: 559-62. (Retrospective analysis all patients admitted with iron poisoning [serum iron >300 µg/dL] to a single Canadian referral center over a 20 year period identified 73 cases, only 13 of which had hepatotoxicity which was severe in 9 [15%] and fatal in 4; all severe cases had serum iron levels >1000 μg/dL on admission compared to levels of <704 µg/dL in those without liver injury; no mention of bilirubin or INR levels). 16323571
Wood DM, Thomson AH, Lawes M, Jones AL, Dargan PI. Hepatocellular damage following therapeutic intravenous iron sucrose infusion in a child. Ther Drug Monit 2005; 27: 405-8. (3 year old boy with refractory iron deficiency anemia developed iron poisoning at end of an infusion of iron sucrose [242 mg iv over 3 hours], with abdominal pain, nausea, vomiting and ALT rise to 810 U/L [13 hours after], resolving rapidly). 16044093
Daram SR, Hayashi PH. Acute liver failure due to iron overdose in an adult. South Med J 2005; 98: 241-4. (18 year old woman took an overdose of ferrous sulfate [100 tablets, ~30 g] and rapidly developed nausea, vomiting, abdominal pain and diarrhea [serum iron 340 μg/dL], with abnormal liver tests starting on day 2 [bilirubin 3.1 mg/dL, ALT rising to 4048 U/L, Alk P 87 U/L, INR 5.0], resolving within 1 week: Case 1). 15759960
Madiwale T, Liebelt E. Iron: not a benign therapeutic drug. Curr Opin Pediatr 2006; 18: 174-9. (Review of pathophysiology, clinical presentation, diagnosis and management of acute iron poisoning in children). 16601499
Tenenbein M. Unit-dose packaging of iron supplements and reduction of iron poisoning in young children. Arch Pediatr Adolesc Med 2005; 159: 557-60. (Analysis of reports of iron poisoning in children <6 years old in the US between 1988 and 2002 demonstrated a significant decrease in reports between the first 10 year period [1988-97: 2.91 per 1000 calls with 29 deaths] and the subsequent 5 years [1998-2000: 1.91 per 1000 calls with only 1 death], coinciding with the FDA requirement for unit dose packaging of iron tablets with more than 30 g of elemental iron). 15939855
Haig A, Driman DK. Iron-induced mucosal injury to the upper gastrointestinal tract. Histopathology 2006; 48: 808-12. (25 instances of upper gastrointestinal mucosal injury due to iron, with erosive mucosal injury attributed to direct effect of the oral iron). 16722929
Skoczynska A, Kwiecinska D, Kielbinski M, Lukaszewski M. Acute iron poisoning in adult female. Hum Exp Toxicol 2007; 26: 663-6. (27 year old woman with sideroblastic anemia received both oral and parenteral iron [~4 g orally and 0.7 g im and iv] and developed nausea, vomiting, diarrhea followed by hypotension with respiratory, renal and hepatic failure, resolving slowly with supportive and deferoxamine therapy). 17884954
Ng HW, Tse ML, Lau FL, Chu W. Endoscopic removal of iron bezoar following acute overdose. Clin Toxicol (Phila) 2008; 46: 913-5. (45 year old woman took an overdose of iron sulfate [~100 tablets] and developed nausea, vomiting and diarrhea and hypotension and was found to have a gastric bezoar of iron tablets which was removed endoscopically, whereupon she recovered). 18608283
Toledano M, Kozer E, Goldstein LH, Abu-Kishk I, Bar-Haim A, Siman-Tov Y, Rechavi M, et al. Hepcidin in acute iron toxicity. Am J Emerg Med 2009; 27: 761-4. (Study in rats showing that serum iron and hepcidin levels increase with large oral iron ingestion). 19683100
Chang TP, Rangan C. Iron poisoning: a literature-based review of epidemiology, diagnosis, and management. Pediatr Emerg Care 2011; 27: 978-85. (Review of iron poisoning including incidence, effects of unit dose packaging, formulations, pathophysiology of injury, clinical course and stages, diagnostic testing, and treatments such as gastric lavage, whole bowel irrigation, and oral and iv chelation with deferoxamine). 21975503
Audimoolam VK, Wendon J, Bernal W, Heaton N, O'Grady J, Auzinger G. Iron and acetaminophen a fatal combination? Transpl Int 2011; 24: e85-8. (3 cases of overdose with multiple agents, including iron in 3 and acetaminophen in 2 which were followed by severe and complicated acute liver failure [AST 1,334-11,555 U/L, iron 394, 1202 and 915 μg/dL], 1 patient dying and 2 undergoing liver transplantation, but then dying of postoperative opportunistic infections). 21883506
Bøg S, Høg LC, Dalhoff KP, Mortensen OS. Status and trends in poisonings in Denmark 2007-2009. Dan Med Bull 2011; 58: A4268. (Over a 3 year period, there were 37,205 reports to Danish poisoning centers, of which 57 [0.15%] were attributed to iron and there was a 3 fold increase in these cases over the 3 year period). 21535985
Griffith EA, Fallgatter KC, Tantama SS, Tanen DA, Matteucci MJ. Effect of deferasirox on iron absorption in a randomized, placebo-controlled, crossover study in a human model of acute supratherapeutic iron ingestion. Ann Emerg Med 2011; 58: 69-73. (Study in 8 healthy volunteers, showed that oral deferasirox decreases iron absorption if administered within 1 hour of taking a standard dose of oral ferrous sulfate). 21288598
Diaz M, Cabrerizo S, Docampo PC. [Ferrous sulfate: acute poisoning with a frequent use drug]. Arch Argent Pediatr 2011; 109: 1-3. Spanish. (4 year old boy swallowed 30 ferrous sulfate tablets, developed nausea, vomiting and lethargy [serum iron 353 μg/dL], followed by acidosis, but recovered with deferoxamine therapy, ALT remaining normal throughout). 21283930
Jayashree M, Singhi S. Changing trends and predictors of outcome in patients with acute poisoning admitted to the intensive care. J Trop Pediatr 2011 Oct; 57: 340-6. (Among 225 children admitted for [largely accidental] poisoning to a single pediatric intensive care unit in a referral hospital in India over a 16 year period, 27 [12%] were for iron poisoning, which accounted for 5 of the 20 deaths). 20978013
Magdalan J, Zawadzki M, Sozanski T. Fulminant hepatic failure in woman with iron and non-steroidal anti-inflammatory drug intoxication. Hum Exp Toxicol 2011; 30: 1106-11. (17 year old girl took 50 tablets of iron sulfate, 15 of naproxen and 5 of ibuprofen in a suicide attempt, developed nausea, vomiting and diarrhea [iron 2351 μg/dL], was treated with deferoxamine, liver tests becoming abnormal on day 2 [bilirubin 9.3 mg/dL, ALT 12,538 U/L, INR 6.03], with subsequent shock, coagulopathy, respiratory and renal failure and death at 80 hours after ingestion). 20952452
Bronstein AC, Spyker DA, Cantilena LR Jr, Rumack BH, Dart RC. 2011 Annual report of the American Association of Poison Control Centers' National Poison Data System (NPDS): 29th Annual Report. Clin Toxicol (Phila) 2012; 50: 911-1164. (Annual review of reports of poisoning in the US). 23272763
Gumber MR, Kute VB, Shah PR, Vanikar AV, Patel HV, Balwani MR, Ghuge PP, Trivedi HL. Successful treatment of severe iron intoxication with gastrointestinal decontamination, deferoxamine, and hemodialysis. Ren Fail 2013; 35: 729-31. (18 year old woman took 50 tablets of iron sulfate, developed nausea and vomiting followed by lethargy and acidosis [serum iron 2150 μg/dL], was treated with whole bowel irrigation, deferoxamine and hemodialysis and recovered). 23635030
Sankar J, Shukla A, Khurana R, Dubey N. Near fatal iron intoxication managed conservatively. BMJ Case Rep 2013 Jan 31; 2013. (10 month old girl swallowed 10 iron tablets and presented 3 hours later with nausea, vomiting and dehydration [serum iron 360 μg/dL]; she was treated with whole bowel irrigation and deferoxamine and recovered within 3 days). 23376661
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to iron). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to iron). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none of which were attributed to iron, given chronically or as an acute overdose). 25754159
Stockwell BR, Friedmann Angeli JP, Bayir H, Bush AI, Conrad M, Dixon SJ, Fulda S, Get ak. Ferroptosis: a regulated cell death nexus linking metabolism, redox biology, and disease. Cell 2017; 171: 273-85. (Review of the molecular pathways involved in ferroptosis, a form of regulated cell death that involves iron and glutathione metabolism). 28985560
Devarbhavi H, Patil M, Reddy VV, Singh R, Joseph T, Ganga D. Drug-induced acute liver failure in children and adults: Results of a single-centre study of 128 patients. Liver Int 2017 Dec 9. [Epub ahead of print]. (Among 128 cases of acute, drug induced liver failure enrolled in a prospective study in Bangalore, India, most cases were due to antituberculosis medications, but 2 were due to intentional overdose with ferrous sulfate, 1 of which was fatal). 29222960
Lands R, Isang E. Secondary Hemochromatosis due to chronic oral iron supplementation. Case Rep Hematol 2017; 2017: 2494167. (78 year old woman who had taken 1-3 tablets of ferrous sulfate for 30 years was found to have high serum ferritin levels [1379 ng/mL] and hepatic iron overload [6153 ug/g] despite absence of C282Y, H53D and S65C variants of HFE, with normal serum aminotransferase levels and no hepatic fibrosis). 28133557

## OTHER REFERENCE LINKS

1. Recent References on Iron: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(fluoxetine)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Iron: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluoxetine)